# Zonisamide

## OVERVIEW

### Introduction

Zonisamide is a new generation anticonvulsant that is typically used in combination with other antiepileptic medications for partial onset seizures. Zonisamide has not been associated with elevations in serum aminotransferase levels and clinically apparent drug induced liver disease has been reported with its use but is very rare.

### Background

Zonisamide (zoe nis' a mide) is synthetic sulfonamide derivative related somewhat in structure to acetazolamide, but not to other anticonvulsant medications. Zonisamide appears to block the spread of seizure discharges by affecting repetitive firing of voltage-sensitive sodium and calcium channels and stabilizing neuronal membranes. Zonisamide was approved for use in epilepsy in Japan in 1989 and in the United States in 2000. Current indications include adjunctive therapy for partial seizures in adults. Zonisamide is used off-label for therapy of migraine headaches, mood disturbances and recently for weight loss. Zonisamide is available as capsules of 25, 50 and 100 mg generically and under the brand name of Zonegran. The recommended initial dose in adults with epilepsy is 100 mg in one or two doses daily, with dose escalation based upon tolerance and effect to a maximum of 200 mg twice daily. Common side effects include drowsiness, dizziness, headache, nausea, poor appetite and weight loss. Rare, but serious side effects include Stevens-Johnson syndrome, toxic epidermal necrolysis, aplastic anemia and agranulocytosis.

### Hepatotoxicity

Prospective studies suggest that chronic zonisamide therapy may be accompanied by mild increases in serum alkaline phosphatase levels, but it has not been linked to significant increases in serum aminotransferase levels during treatment. Clinically apparent hepatotoxicity from zonisamide is rare, but several case reports of hepatic injury linked to zonisamide have been published. Zonisamide is typically used in combination with other anticonvulsants and its separate role in causing liver injury is often difficult to delineate. Zonisamide has been linked to a single case report of cholestatic hepatitis associated with vanishing bile duct syndrome that ultimately resolved. More commonly, zonisamide has been linked to cases of hypersensitivity (DRESS syndrome or Stevens-Johnson syndrome) with rash, fever, eosinophilia, renal failure and/or mild liver test abnormalities. In most instances, the hepatic injury was cholestatic and arose 3 to 8 weeks after starting therapy. Autoantibodies are usually not present. Interestingly, a similar cholestatic liver injury has been described in dogs receiving zonisamide.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

Mechanism of Injury

The mechanism of zonisamide hepatotoxicity is unknown but is likely to be hypersensitivity. Cases of drug hypersensitivity to zonisamide have been linked to HLA-A*02:07 in Japanese subjects.

### Outcome and Management

A few cases of cholestatic liver injury attributed to zonisamide has been published, with complete recovery in most patients but with persistent liver test abnormalities in at least one patient. Zonisamide has not been linked to acute liver failure or chronic liver injury. Patients who develop the anticonvulsant hypersensitivity syndrome should avoid other aromatic anticonvulsants or start them only with careful monitoring. Hypersensitivity reactions to anticonvulsants including zonisamide may benefit from corticosteroid therapy, but the efficacy of such therapy in altering the outcome of liver injury has not been proven.

Drug Class: Anticonvulsants

## CASE REPORT

### Case 1. Cholestatic hepatitis and bile duct injury attributed to zonisamide.(1)

An obese 35 year old man was being treated with phentermine and topiramate for weight loss. When switched from topiramate to zonisamide, he developed fatigue, dark urine and abdominal pain followed by jaundice and itching. After 3 weeks of symptoms, laboratory testing showed significant elevations in serum bilirubin, ALT and alkaline phosphatase levels (Table). There was no rash or fever. Tests for hepatitis A, B and C and for autoantibodies were negative. Abdominal ultrasound showed echogenicity of the liver compatible with hepatic steatosis, but no evidence of biliary obstruction. Endoscopic retrograde cholangiopancreatography was normal and a liver biopsy showed cholestasis with paucity of bile ducts. He persisted in having elevations in serum enzymes and underwent repeat liver biopsies 3 and 7 months after presentation, which showed ductular proliferation and improvement in cholestasis.

#### Key Points

Medication: | Zonisamide (dose not provided)
Pattern: | Mixed→Cholestatic (R=2.3, initially; later R <1.0)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 weeks
Recovery: | Incomplete; alkaline phosphatase still elevated one year later
Other medications: | Phentermine, topiramate (stopped 3 weeks earlier)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 weeks | 0 | 531 | 578 | 7.1
4 weeks | 1 week | 240 | 490 | 9.0
5 weeks | 2 week | 270 | 390 | 9.5 | Biopsy #1
6 weeks | 3 week | 100 | 320 | 8.2
7 weeks | 4 week | 80 | 300 | 7.3
11 weeks | 8 week | 90 | 320 | 5.6
13 weeks | 10 weeks | 200 | 420 | 3.0
15 weeks | 12 weeks | 110 | 510 | 2.0
21 weeks | 18 weeks | 75 | 340 | 1.7 | Biopsy #2
6 months | 5 months | 105 | 440 | 1.2
1 year | 11 months | 120 | 640 | 0.9 | Biopsy #3
Normal Values | | <50 | <125 | <1.2

#### Comment

This was a well documented example of cholestatic hepatitis presenting with histological features of bile duct injury and loss which evolved into a partially reversible bile duct vanishing syndrome. The patient had persistence of serum enzyme elevations and chronic ductular injury with decrease in numbers of bile ducts that was still present almost a year after onset. The injury was attributed to zonisamide, but the patient had also received topiramate that was withdrawn shortly before onset of symptoms and may have played a role in this injury. The ultimate prognosis of vanishing bile duct syndrome is variable; some patients appear to recover, others develop chronic cholestasis and cirrhosis, requiring liver transplantation.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zonisamide – Generic, Zonegran®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zonisamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zonisamide | 68291-97-4 | C8-H8-N2-O3-S

## CITED REFERENCE

1 Vuppalanchi R, Chalasani N, Saxena R. (2006). Restoration of bile ducts in drug-induced vanishing bile duct syndrome due to zonisamide. Am J Surg Pathol.

## ANNOTATED BIBLIOGRAPHY

References updated: 31 July 2020

Abbreviations used: DRESS, drug rash with eosinophilia and systemic symptoms; SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; zonisamide is not mentioned).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury does not specifically discuss zonisamide).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Natsch S, Hekster YA, Keyser A, Deckers CL, Meinardi H, Renier WO. (1997). Newer anticonvulsant drugs: role of pharmacology, drug interactions and adverse reactions in drug choice. Drug Saf. (Review of pharmacology, drug interactions and adverse effects anticonvulsants introduced after 2007, including felbamate, gabapentin, lamotrigine, oxcarbazepine, topiramate and zonisamide; no mention of hepatotoxicity of zonisamide).
Knowles SR, Shapiro LE, Shear NH. (1999). Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Role of corticosteroids uncertain; cross reactivity among the aromatic anticonvulsant agents should be assumed, but not with zonisamide).
Hamer HM, Morris HH. (1999). Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Cleve Clin J Med. (Clinical review of anticonvulsant hypersensitivity syndrome, which occurs in 1-5/10,000 of users, higher risk in African Americans and affected siblings; liver involvement common, but most cases are anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis; switching to valproate and benzodiazepines is safe, zonisamide is also an option).
Leppik IE. (2004). Zonisamide: chemistry, mechanism of action, and pharmacokinetics. Seizure. (Review of the pharmacology and pharmacokinetics of zonisamide).
Vuppalanchi R, Chalasani N, Saxena R. (2006). Restoration of bile ducts in drug-induced vanishing bile duct syndrome due to zonisamide. Am J Surg Pathol. (35 year old obese man developed fatigue and dark urine shortly after starting zonisamide and 3 weeks later had jaundice and itching [bilirubin 7.1 mg/dL, ALT 531 U/L, Alk P 531], biopsy showing bile duct loss, Alk P and ALT were still abnormal 10 months later; patient also had received topiramate 3 weeks before presentation: Case 1).
LaRoche SM. (2007). A new look at the second-generation antiepileptic drugs: a decade of experience. Neurologist. (Review of second generation anticonvulsants approved since 1994 including felbamate, gabapentin, lamotrigine, topiramate, tiagabine, levetiracetam, oxcarbazepine, zonisamide and pregabalin; zonisamide associated with kidney stones, but no mention of liver toxicity).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of all anticonvulsants; suggests that there have been no cases of hepatoxicity associated with zonisamide).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each; zonisamide not mentioned).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 11 due to anticonvulsants, 8 from phenytoin, 2 valproate and 3 carbamazepine, but none were attributed to lamotrigine, levetiracetam, topiramate, or zonisamide).
Fujita Y, Hasegawa M, Nabeshima K, Tomita M, Murakami K, Nakai S, Yamakita T, Matsunaga K. (2010). Acute kidney injury caused by zonisamide-induced hypersensitivity syndrome. Intern Med. (29 year old man developed rash, facial edema and fever 2 months after starting zonisamide, with subsequent renal failure requiring dialysis and serum cholestatic enzyme elevations [bilirubin 0.4 mg/dL, ALT 88 U/L, Alk P 661 U/L, 26% eosinophils], with response to corticosteroid therapy and ultimate resolution).
Schwartz M, Muñana KR, Olby NJ. (2011). Possible drug-induced hepatopathy in a dog receiving zonisamide monotherapy for treatment of cryptogenic epilepsy. J Vet Med Sci. (9 year old female dog developed jaundice 3 weeks after starting zonisamide [bilirubin 4.3 mg/dL, ALT 1275 U/L, Alk P 5182 U/L], with full recovery within 4 weeks of stopping).
Miller ML, Center SA, Randolph JF, Lepherd ML, Cautela MA, Dewey CW. (2011). Apparent acute idiosyncratic hepatic necrosis associated with zonisamide administration in a dog. J Vet Intern Med. (4 year old male dog developed anorexia and vomiting 10 days after starting zonisamide for epilepsy [bilirubin 2.3 mg/dL, ALT 16,328 U/L, Alk P 354 U/L], with progressive multiorgan failure and death the next day, autopsy showing massive necrosis).
Lu Y, Xiao Z, Yu W, Xiao F, Xiao Z, Hu Y, Chen Y, Wang X. (2011). Efficacy and safety of adjunctive zonisamide in adult patients with refractory partial-onset epilepsy: a randomized, double-blind, placebo-controlled trial. Clin Drug Investig. (Controlled trial of zonisamide in 104 patients with refractory epilepsy; liver enzyme elevations occurred in 35% of zonisamide- vs 37% of placebo-recipients and none developed clinically apparent liver injury).
Uhara H, Saiki M, Kawachi S, Ashida A, Oguchi S, Okuyama R. (2013). Clinical course of drug-induced hypersensitivity syndrome treated without systemic corticosteroids. J Eur Acad Dermatol Venereol. (Series of 12 patients with drug induced hypersensitivity caused by carbamazepine [6], sulfonamide [4], mexiletine [1], and zonisamide [1]; in a 62 year old woman with a brain tumor who developed fever and rash 22 days after starting zonisamide [bilirubin and Alk P not given, ALT 240 U/L], resolving without therapy).
Kaniwa N, Saito Y. (2013). Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet. (Review of genetic associations with severe skin and liver injury from drugs, focusing upon allopurinol [B*58:01], abacavir and flucloxacillin [B*57:01] and lapatinib [DQA1*02:01]; the association of B*15:02 with carbamazepine induced SJS has not been extended to carbamazepine induced liver injury; zonisamide not discussed).
Sekula P, Dunant A, Mockenhaupt M, Naldi L, Bouwes Bavinck JN, Halevy S, Kardaun S, Sidoroff A, Liss Y, Schumacher M, Roujeau JC. (2013). Comprehensive survival analysis of a cohort of patients with Stevens-Johnson syndrome and toxic epidermal necrolysis. J Invest Dermatol. (Analysis of mortality rates in 460 patients with SJS/TEN [67% due to drugs and 19% due to anticonvulsants] in a European observational database found that age, severity, underlying malignancy and renal or hepatic involvement correlated with poor survival; overall mortality at one year being 24% for SJS, 43% for overlap and 49% for TEN cases).
Lee T, Lee YS, Yoon SY, Kim S, Bae YJ, Kwon HS, Cho YS, et al. (2013). Characteristics of liver injury in drug-induced systemic hypersensitivity reactions. J Am Acad Dermatol. (Analysis of 136 patients with hypersensitivity reactions to drugs seen at a single referral center in Korea found liver involvement in 61 [45%], including 11 with SJS/TEN, 29 with DRESS and 17 with rash only; 20 cases were attributed to anticonvulsants, but specific agents were not mentioned).
Gaitatzis A, Sander JW. (2013). The long-term safety of antiepileptic drugs. CNS Drugs. (Review of the long term safety and adverse event profile of anticonvulsants mentions that valproate can cause fatty liver disease, but that most cases of clinically apparent liver injury including acute liver failure occur within the first few months of treatment with anticonvulsants such as valproate and felbamate).
Kaniwa N, Sugiyama E, Saito Y, Kurose K, Maekawa K, Hasegawa R, Furuya H, et al., Japan Pharmacogenomics Data Science Consortium. (2013). Specific HLA types are associated with antiepileptic drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Japanese subjects. Pharmacogenomics. (Analysis of HLA types among 12 Japanese patients with SJS/TEN due to zonisamide four 42% to have HLA-A*02:07 compared to 6.8% of controls).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of drugs of choice for epilepsy; mentions that the adverse effects of zonisamide include fatal instances of toxic epidermal necrolysis and Stevens-Johnson syndrome).
Shibuya R, Tanizaki H, Nakajima S, Koyanagi I, Kataoka TR, Miyachi Y, Kabashima K. (2015). DIHS/DRESS with remarkable eosinophilic pneumonia caused by zonisamide. Acta Derm Venereol. (46 year old woman developed rash, fever and cough 41 days after restarting zonisamide [bilirubin normal, ALT 133 U/L, Alk P 220 U/L, 11% eosinophils], resolving with prednisone therapy).
Baulac M, Patten A, Giorgi L. (2014). Long-term safety and efficacy of zonisamide versus carbamazepine monotherapy for treatment of partial seizures in adults with newly diagnosed epilepsy: Results of a phase III, randomized, double-blind study. Epilepsia. (Among 295 patients with partial seizures treated with either zonisamide or carbamazepine for 6 months, adverse events were similar with both drugs; no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including 3 to phenytoin, 3 to valproate and 1 to carbamazepine, but none were attributed to zonisamide).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 12 due to phenytoin, 9 lamotrigine, 7 valproate, 4 carbamazepine, 3 gabapentin, 2 topiramate and 1 each for ethosuximide, fosphenytoin, and pregabalin).
Lee HJ, Son JM, Mun J, Kim DW. (2015). Safety and efficacy of zonisamide in patients with epilepsy: a post-marketing surveillance study. J Epilepsy Res. (Among 1948 Korean adults treated with zonisamide and monitored in a postmarketing study, 65 patients [3.3%] reported an adverse event, 11 of which [0.5%] were considered serious, including one case of Stevens-Johnson syndrome; no mention of hepatotoxicity or ALT elevations).
Dash A, Ravat S, Srinivasan AV, Shetty A, Kumar V, Achtani R, Mathur VN, et al. (2016). Evaluation of safety and efficacy of zonisamide in adult patients with partial, generalized, and combined seizures: an open labeled, noncomparative, observational Indian study. Ther Clin Risk Manag. (Among 655 adults with partial, generalized or combined seizures treated with zonisamide [add on to other agents in 79%] for 24 weeks, most patients had improvement in seizure control and adverse events included loss of appetite [7%], weight loss [4%], sedation [2%], dizziness [2%] and skin rash [<1%] but no mention of hepatotoxicity or ALT elevations).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam, being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy mentions that zonisamide is approved as adjunctive therapy of partial seizures but has a broad spectrum of action, while common adverse events include somnolence, dizziness, confusion, anorexia, nausea, diarrhea, weight loss, agitation, irritability and rash, rare but severe events include Stevens-Johnson syndrome aplastic anemia, agranulocytosis, metabolic acidosis and renal stones).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8] and zonisamide [7]; no mention of accompanying liver injury or whether attribution was as a single agent or one of several).
Han XD, Koh MJ, Wong SMY. (2019). Drug reaction with eosinophilia and systemic symptoms in a cohort of Asian children. Pediatr Dermatol. (Among 10 children with DRESS syndrome seen at a single, Singapore referral center between 2006 and 2016, 3 cases were attributed to sulfamethoxazole/trimethoprim, 2 to carbamazepine, 1 sulfasalazine, 2 phenobarbital, 1 to levetiracetam [latency 28 days] but none to zonisamide; all had ALT elevations [88 to 1172 U/L], bilirubin was elevated in 7, but none had acute liver failure and none were fatal).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).

## OTHER REFERENCE LINKS

1 Recent References on Zonisamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(zonisamide+AND+isoxazoles/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Zonisamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=zonisamide)